# Lenalidomide

## OVERVIEW

### Introduction

Lenalidomide is an immunomodulatory and antineoplastic agent that is used in the therapy of multiple myeloma. Lenalidomide is associated with a low rate of serum aminotransferase elevations during therapy and has been implicated in causing rare instances of clinically apparent liver injury which can be severe.

### Background

Lenalidomide (len" a lid' oh mide) is a thalidomide derivative that has similar but more potent activity as an antineoplastic agent. Thalidomide and its derivatives have immunomodulatory, antiinflammatory antiangiogenic and antineoplastic activities. The mechanism of action of these agents in the treatment of multiple myeloma is not well defined but may relate to inhibition of tumor necrosis factor (TNF) alpha, a potent proinflammatory cytokine or to stimulation of T and NK cell activity. The thalidomide derivatives have direct cytotoxic effects against myeloma cells in culture and have potent antiangiogenic activities. Lenalidomide was approved for use in multiple myeloma in 2005 and was subsequently approved for use in myelodysplastic syndromes and mantle cell lymphoma. Lenalidomide is available in capsules of 2.5, 5, 10, 15, 20 and 25 mg under the brand name Revlimid. The recommended doses vary by indication and, like thalidomide, its use is restricted because of proven teratogenicity. Side effects of lenalidomide are common and include sedation, dizziness, orthostatic hypotension, neutropenia, lymphopenia, peripheral neuropathy, and arterial and venous thromboembolism (for which reason it is often given with anticoagulation). Rare but potentially severe adverse events include severe cutaneous reactions, seizures, tumor lysis syndrome and hypersensitivity reactions. Lenalidomide is a teratogen and possible cause of severe birth defects and is available only as a part of a strict Risk Evaluation and Mitigation Strategy (REMS), which requires physician training, written patient informed consent, strict birth control measures, regular monitoring and reporting.

### Hepatotoxicity

Serum enzyme elevations occur in 8% to 15% of patients taking lenalidomide and are more frequent with higher doses. The enzyme abnormalities are usually mild and self-limited, and only rarely require drug discontinuation. In addition, lenalidomide has been implicated in rare instances of clinically apparent, acute liver injury which can be severe and has led to deaths from acute liver failure. The onset of injury is typically within 1 to 8 weeks of starting therapy. The pattern of serum enzyme elevation at the time of presentation can be either hepatocellular or cholestatic; however, the injury tends to be cholestatic and can be prolonged. Immunoallergic and autoimmune features are not common. Several instances of acute liver injury associated with lenalidomide therapy have occurred in patients with other apparent causes of liver disease or with preexisting chronic hepatitis B or C. If performed during the acute injury, liver biopsy shows hepatocellular necrosis and inflammatory cell infiltration, consistent with acute drug induced injury. In some instances there is bile duct injury and loss resulting in progressive cholestatic liver injury suggestive of vanishing bile duct syndrome. Lenalidomide has also been shown to increase indirect bilirubin levels in patients with underlying Gilbert syndrome, causing a mild hyperbilirubinemia during therapy that soon resolves with stopping treatment and is otherwise benign.

Thalidomide and its derivatives have also been implicated in causing an increased risk of graft-vs-host disease after autologous or allogeneic hematopoietic stem cell transplantation (HSCT) as well as after liver, kidney and heart transplantation. There appears to be cross reactivity to this complication among lenalidomide, pomalidomide and thalidomide. Therapy usually requires discontinuation of the antineoplastic agent as well as treatment with high doses of corticosteroids and tacrolimus or sirolimus. Furthermore, hepatic graft-vs-host disease can occasionally present with an acute hepatitis that resembles hepatocellular drug induced liver injury.

Reactivation of hepatitis B has been reported in patients receiving thalidomide, lenalidomide and pomalidomide, but generally only after HSCT and the role of these agents in causing reactivation is not always clear. Indeed, in studies of large numbers of patients treated for multiple myeloma, the major risk factor for reactivation was found to be HSCT rather than the specific antineoplastic drugs being used. Indeed, lenalidomide therapy is associated with a reduced risk of reactivation in patients with HSCT (although dexamethasone, thalidomide and bortezomib were not), perhaps because of the immune enhancement typically caused by lenalidomide.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of lenalidomide hepatotoxicity is not clear, but it may be related to its activity in reducing TNF-α production, a potent inflammatory cytokine that activates T cells and promotes inflammation, but is also necessary for normal liver regeneration. Several of the reported cases of hepatotoxicity have occurred in patients with underlying chronic liver disease (hepatitis B, C or nonalcoholic fatty liver), and another possibility is that lenalidomide may worsen preexisting hepatic conditions.

### Outcome and Management

The severity of lenalidomide induced liver injury ranges from transient, asymptomatic elevations in serum enzymes to acute liver injury with jaundice to severe acute liver failure and death. The liver injury usually starts to resolve within a week of stopping the medication, but prolonged jaundice with bile duct injury and possible vanishing bile duct syndrome have also been reported. Rechallenge should be reserved for cases of mild liver injury in which the agent is considered very necessary and done with caution and careful monitoring. Nevertheless, instances of reinitiation of therapy without subsequent recurrence of liver injury have been reported.

Drug Class: Antineoplastic Agents, Miscellaneous

Other Related Drugs: Pomalidomide, Thalidomide

## CASE REPORT

### Case 1. Acute liver injury during lenalidomide therapy of multiple myeloma.(1)

A 50 year old man with refractory and relapsed multiple myeloma was started on a course of lenalidomide after multiple cycles of chemotherapy and both autologous and allogeneic hematopoietic stem cell transplants that provided only temporary remissions. Ten days after starting lenalidomide [10 mg daily], he was found to have abnormal liver tests with a serum ALT of 505 U/L, AST 246 U/L, Alk P 198 U/L, but bilirubin and INR normal. Serum enzyme levels had been normal before starting lenalidomide. He did not drink alcohol and had no risk factors for viral hepatitis. Of note, 3 years earlier he had developed angioedema and a severe skin rash without liver test abnormalities after three months of cyclic lenalidomide therapy. In the interim he had undergone an allogeneic HSCT.

Lenalidomide was discontinued and he was admitted for evaluation and liver biopsy. Blood counts demonstrated eosinophilia (1344/µL). Tests for hepatitis A, B, C and E as well as CMV, EBV, HIV and herpes simplex and zoster infection were negative. Ultrasound showed normal appearing liver without evidence of biliary obstruction. Liver biopsy showed prominent portal and lobular inflammation with a mixed cellular infiltrate rich in eosinophils, lobular areas with confluent necrosis and mild endothelitis and occasional biliary cell injury in portal areas. The liver histology was considered consistent with an acute drug induced hepatitis superimposed upon mild graft-vs-host disease. In further follow up, liver tests improved and were normal 6 weeks later (Table).

#### Key Points

Medication: | Lenalidomide (10 mg daily for 10 days)
Pattern: | Hepatocellular (R value 8.4)
Severity: | 1+ (anicteric, asymptomatic)
Latency: | 10 days
Recovery: | Complete within 35 days
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | | Normal | Normal | Normal
10 days | 0 | 505 | 198 | Normal
11 days | 1 day | 510 | 230
12 days | 2 days | 515 | 255
17 days | 7 days | 219 | 157 | Normal | Admission, Liver Biopsy
24 days | 14 | 80 | 110
4 weeks | 21 days | 45 | 95
6 weeks | 35 days | 35 | 85
Upper limits of normal | | <40 | <130 | <1.2

* Some values estimated from Figure 1. Upper limits of normal used standard values

#### Comment

This man developed asymptomatic and anicteric hepatitis within 10 days of starting lenalidomide. Typical of lenalidomide hepatotoxicity was the rapid latency to onset (less than one month), the hepatocellular pattern of injury, and the rapid improvement with stopping the medication. Also typical was the previous history of autologous or allogeneic HSCT. Indeed, one possibility is that this represented the worsening of an underlying graft-vs-host disease by lenalidomide therapy, an indirect form of drug induced liver injury. In preparation of use of lenalidomide to treat multiple myeloma, maintenance immunosuppressive therapy for prevention of graft-vs-host disease is typically withdrawn. In this case, it was unclear whether maintenance immunosuppression was continued.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAME

Lenalidomide – Revlimid®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lenalidomide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Thalidomide | 50-35-1 | C13-H10-N2-O4
Lenalidomide | 191732-72-6 | C13-H13-N3-O3
Pomalidomide | 19171-19-8 | C13-H11-N3-O4

## CITED REFERENCE

1 Zanella MC, Rubbia-Brandt L, Giostra E, Chalandon Y, Hadengue A, Spahr L. (2011). A case of drug-induced hepatitis due to lenalidomide. Case Rep Gastroenterol.

## ANNOTATED BIBLIOGRAPHY

References updated: 30 August 2022

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999; lenalidomide is not discussed).
Davern TJ. Hepatotoxicity of immunomodulating agents and the transplant situation. Thalidomide. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, p. 675. (Mentions that thalidomide rarely causes liver injury, but case reports of hepatocellular injury with variable degrees of jaundice have been described, largely in patients with preexisting chronic liver disease; no mention of lenalidomide).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Thalidomide and Lenalidomide. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1225-27. (Textbook of pharmacology and therapeutics).
Hastings RC, Trautman JR, Enna CD, Jacobson RR. (1970). Thalidomide in the treatment of erythema nodosum leprosum. With a note on selected laboratory abnormalities in erythema nodosum leprosum. Clin Pharmacol Ther. (Results of treating 22 patients with leprosy with thalidomide showed excellent results, often allowing for discontinuation of corticosteroids without significant toxicity).
Tseng S, Pak G, Washenik K, Pomeranz MK, Shupack JL. (1996). Rediscovering thalidomide: a review of its mechanism of action, side effects, and potential uses. J Am Acad Dermatol. (Review of history, mechanism of action, side effects and uses of thalidomide; thalidomide has many side effects, but hepatic adverse events were not mentioned).
Singhal S, Mehta J, Desikan R, Ayers D, Roberson P, Eddlemon P, Munshi N, et al. (1999). Antitumor activity of thalidomide in refractory multiple myeloma. N Engl J Med. (Trial of oral thalidomide in 84 patients with advanced myeloma found some response in 78% and remissions in 10%; adverse events were common, but no mention of ALT elevations or liver injury).
Clark TE, Edom N, Larson J, Lindsey LJ. (2001). Thalomid (Thalidomide) capsules: a review of the first 18 months of spontaneous postmarketing adverse event surveillance, including off-label prescribing. Drug Saf. (During first 18 months of postmarketing use of thalidomide in 10,456 patients, 1210 adverse event reports were received, including 4 cases of hepatic failure arising after 1-4 weeks of treatment, although 3 were considered unrelated to therapy).
Fowler R, Imrie K. (2001). Thalidomide-associated hepatitis: a case report. Am J Hematol. (Patient with chronic hepatitis C and advanced plasma cell leukemia developed jaundice and nausea 1 week after starting thalidomide [bilirubin 0.4 initially rising to 9.3 mg/dL, ALT 91 to 829 U/L, Alk P 100 to 120 U/L], resolving rapidly upon stopping; high HCV RNA levels noted).
Grover JK, Uppal G, Raina V. (2002). The adverse effects of thalidomide in relapsed and refractory patients of multiple myeloma. Ann Oncol. (Report of adverse effects of thalidomide in 23 patients with myeloma: constipation 100%, sedation 87%, edema 70%, also common were dry skin and mouth, headache, nausea and rash; minor ALT elevations occurred and 1 patient developed acute hepatitis, but it was attributed to hepatitis C).
Trojan A, Chasse E, Gay B, Pichert G, Taverna C. (2003). Severe hepatic toxicity due to thalidomide in relapsed multiple myeloma. Ann Oncol. (62 year old woman with multiple myeloma developed acute liver failure after 7 months of thalidomide therapy [bilirubin not given, ALT ~2000 U/L, LDH ~6000 U/L], enzymes falling to normal in 1 week; overall, suggestive of ischemic hepatitis rather than hepatotoxicity).
Teo SK. (2005). Properties of thalidomide and its analogues: implications for anticancer therapy. AAPS J. (Review of the properties and experimental uses of thalidomide as an inhibitor of TNF-α and other cytokines in multiple myeloma and several solid tumors).
List A, Kurtin S, Roe DJ, Buresh A, Mahadevan D, Fuchs D, Rimsza L, et al. (2005). Efficacy of lenalidomide in myelodysplastic syndromes. N Engl J Med. (Open label study of lenalidomide in 43 patients with myelodysplasia and anemia due to myelodysplastic syndrome reported neutropenia in 65% and thrombocytopenia in 74% of patients, and need for dose modification in 25%, but no mention of liver abnormalities).
Caseiro MM. (2006). Treatment of chronic hepatitis C in non-responsive patients with pegylated interferon associated with ribavirin and thalidomide: report of six cases of total remission. Rev Inst Med Trop Sao Paulo. (Report of improvement in virological and biochemical responses to peginterferon and ribavirin therapy of chronic hepatitis C by addition of thalidomide [100 mg daily]; no mention of side effects).
Hanje AJ, Shamp JL, Thomas FB, Meis GM. (2006). Thalidomide-induced severe hepatotoxicity. Pharmacotherapy. (Elderly woman with myeloma developed jaundice and marked ALT elevations after 6 weeks of thalidomide therapy [ALT 2205 U/L; bilirubin 5.6 mg/dL], resolving within 3 months of stopping: Case 1 for Thalidomide).
Hamadani M, Benson DM, Copelan EA. (2007). Thalidomide-induced fulminant hepatic failure. Mayo Clin Proc. (64 year old woman with multiple myeloma and HBsAg in serum developed acute liver failure 12 days after starting thalidomide [bilirubin 16.7 mg/dL, ALT 410 U/L, Alk P 101 U/L, no change in HBV DNA], some improvement on stopping drug, but had worsening coagulopathy and renal failure and died 14 days later).
Hussain S, Browne R, Chen J, Parekh S. (2007). Lenalidomide-induced severe hepatotoxicity. Blood. (57 year old man with multiple myeloma renal dysfunction and previous hematopoietic stem cell transplant developed jaundice 1 week after starting lenalidomide, a derivative of thalidomide [bilirubin 7.2 mg/dL, ALT 90 U/L, Alk P 210 U/L], resolving within 3 weeks of stopping).
Weber DM, Chen C, Niesvizky R, Wang M, Belch A, Stadtmauer EA, Siegel D, et al. (2007). Multiple Myeloma (009) Study Investigators. Lenalidomide plus dexamethasone for relapsed multiple myeloma in North America. N Engl J Med. (Controlled trial of lenalidomide in 353 patients with relapsed multiple myeloma showed improvement in response rates and survival time; side effects were common, but no mention of liver abnormalities).
Dimopoulos M, Spencer A, Attal M, Prince HM, Harousseau JL, Dmoszynska A, San Miguel J, et al. (2007). Multiple Myeloma (010) Study Investigators. Lenalidomide plus dexamethasone for relapsed or refractory multiple myeloma. N Engl J Med. (Controlled trial of lenalidomide in 351 patients with refractory multiple myeloma showed improvement in response rates and survival time; side effects of neutropenia, muscle cramps, constipation, nausea and dizziness were common, but liver abnormalities were not mentioned).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to thalidomide or lenalidomide).
Dabak V, Kuriakose P. (2009). Thalidomide-induced severe hepatotoxicity. Cancer Chemother Pharmacol. (2 women with multiple myeloma; 79 year old developed jaundice 7 weeks after starting thalidomide [bilirubin 27.9 mg/dL, ALT 392 U/L, Alk P 1172 U/L], with persistent jaundice, bile duct loss on liver biopsy and death 4 months later; 57 year old developed raised enzymes one month after starting thalidomide [bilirubin not given, ALT 398 U/L, Alk P 175 U/L], resolving within 2 weeks of stopping).
Levesque E, Bradette M. (2009). Hepatotoxicity as a rare but serious side effect of thalidomide. Ann Hematol. (36 year old woman with multiple myeloma developed liver test abnormalities 5 weeks after starting thalidomide [bilirubin normal, peak ALT ~1300 U/L], resolving within 20 days of stopping).
Jain P. (2009). Lenalidomide-induced acute liver failure. Blood Transfus. (93 year old man with myelodysplastic syndrome and HBsAg in serum developed jaundice 10 days after starting lenalidomide [bilirubin 9.2 mg/dL, ALT 2670 U/L, Alk P 342 U/L, IgM anti-HBc positive, but low levels of HBV DNA], resolving over following 4 weeks and patient later tolerated restarting lenalidomide in combination with adefovir, suggesting that the injury was due to acute hepatitis B).
Castaneda CP, Brandenburg NA, Bwire R, Burton GH, Zeldis JB. (2009). Erythema multiforme/Stevens-Johnson syndrome/toxic epidermal necrolysis in lenalidomide-treated patients. J Clin Oncol. (After approximately 57,000 patients had received lenalidomide, the sponsor received 12 reports of Stevens-Johnson Syndrome, 3 of erythema multiforme and 1 of toxic epidermal necrolysis, arising 3-112 days after starting; often sparse data were available and there was no mention of liver injury or jaundice).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to thalidomide or lenalidomide).
Zanella MC, Rubbia-Brandt L, Giostra E, Chalandon Y, Hadengue A, Spahr L. (2011). A case of drug-induced hepatitis due to lenalidomide. Case Rep Gastroenterol. (50 year old man with refractory multiple myeloma and autologous hematopoietic stem cell transplant developed severe skin rash 3 months after starting lenalidomide that resolved upon stopping, but developed serum enzyme elevations one week after restarting lenalidomide 2 years later [bilirubin normal, ALT 509 U/L, Alk P 198 U/L], resolving upon stopping).
Vilas-Boas F, Gonçalves R, Sobrinho Simões M, Lopes J, Macedo G. (2012). Thalidomide-induced acute cholestatic hepatitis: Case report and review of the literature. Gastroenterol Hepatol. (77 year old man with multiple myeloma developed jaundice 4 weeks after starting chemotherapy with melphalan, prednisone and thalidomide [bilirubin 11.4 mg/dL, ALT 333 U/L, Alk P 4 times ULN], worsening for a week after stopping thalidomide and then improving; patient later tolerated melphalan, but died of pneumonia shortly thereafter).
Nojkov B, Signori C, Konda A, Fontana RJ. (2012). Lenalidomide-associated hepatotoxicity--a case report and literature review. Anticancer Res. (67 year old man with multiple myeloma developed fatigue within 1 week of starting a second 3-week course of lenalidomide [bilirubin 4.4 mg/dL, ALT 139 U/L, Alk P 190 U/L], with rapid resolution upon stopping [within 8 days]).
Simondsen KA, Kolesar JM. (2012). Lenalidomide-induced elevated bilirubin. J Oncol Pharm Pract. (55 year old man with polycythemia vera and myelofibrosis developed hyperbilirubinemia after several cycles of lenalidomide [total bilirubin 1.1 to 2.0 with normal direct bilirubin, ALT and Alk P], which decreased when lenalidomide was held and recurred with subsequent cycles, genetic testing demonstrating 7TA allele in UGT1A1 gene typical of Gilbert syndrome).
Sockel K, Bornhaeuser M, Mischak-Weissinger E, Trenschel R, Wermke M, Unzicker C, Kobbe G, et al., German MDS and Cooperative Transplant Study Group (GCTSG). (2012). Lenalidomide maintenance after allogeneic HSCT seems to trigger acute graft-versus-host disease in patients with high-risk myelodysplastic syndromes or acute myeloid leukemia and del(5q): results of the LENAMAINT trial. Haematologica. (Among 10 patients with acute myelogenous leukemia or high risk myelofibrosis who were treated with lenalidomide maintenance therapy 2-4 months after allogenic hematopoietic cell transplantation, 6 developed severe acute graft-vs-host disease within the first 2 cycles of treatment which improved on stopping and recurred in most on restarting lenalidomide).
Meyers DE, Adu-Gyamfi B, Segura AM, Buja LM, Mallidi HR, Frazier OH, Rice L. (2013). Fatal cardiac and renal allograft rejection with lenalidomide therapy for light-chain amyloidosis. Am J Transplant. (68 year old woman with light-chain amyloidosis underwent successful combined heart and kidney transplantation, but 110 days after transplant and 9 days after starting lenalidomide developed severe and ultimately fatal acute cellular rejection of both organs).
Veluswamy RR, Ward SC, Yum K, Abramovitz RB, Isola LM, Jagannath S, Parekh S. (2014). Adverse drug reaction: pomalidomide-induced liver injury. Lancet. (50 year old man with multiple myeloma on lenalidomide and dexamethasone after HCT developed ALT elevations [433 U/L], which resolved on stopping but recurred and worsened when later treated after a second HCT with pomalidomide and dexamethasone [bilirubin 13 mg/dL, ALT 3981 U/L, Alk P 259 U/L], resolving after stopping both drugs, but ultimately requiring corticosteroid therapy).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to thalidomide or its derivatives).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 1 case was attributed to thalidomide but none to lenalidomide).
Mahale P, Thomas SK, Kyvernitakis A, Torres HA. (2015). Management of multiple myeloma complicated by hepatitis C virus reactivation: the role of new antiviral therapy. Open Forum Infect Dis. (74 year old woman with multiple myeloma and chronic hepatitis C had worsening of serum ALT and increase in HCV RNA levels when treated with thalidomide and dexamethasone, which prevented continued therapy until hepatitis C was successfully treated with sofosbuvir and ribavirin).
Safran H, Charpentier KP, Kaubisch A, Mantripragada K, Dubel G, Perez K, Faricy-Anderson K, et al. (2015). Lenalidomide for second-line treatment of advanced hepatocellular cancer: a Brown University oncology group phase II study. Am J Clin Oncol. (Among 40 patients with hepatocellular carcinoma with an inadequate response to sorafenib treated with lenalidomide [25 mg daily for 21 days in 28 day cycles], 6 [15%] had a partial response and toxicities were largely hematologic and rash; 5 patients had ALT elevations above 3 times ULN).
Kootte RS, Faber LM. (2017). Hepatitis E during lenalidomide treatment for multiple myeloma in complete remission. Neth J Med. (69 year old woman with multiple myeloma on lenalidomide after HCT was found to have elevations in liver tests [bilirubin 0.5 mg/dL, ALT 328 U/L, Alk P 241 U/L] accompanied by IgM anti-HEV and HEV RNA [suggesting chronic infection sustained by immunosuppression], viremia and ALT elevations resolving with stopping lenalidomide and not returning when it was restarted).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al., U.S. Drug Induced Liver Injury Network Investigators. (2017). Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss, including 1 case attributed to lenalidomide and 1 to thalidomide both marked by severe, and relentlessly progressive cholestatic liver injury resulting in death from liver failure within 3 months of onset).
Lum EL, Huang E, Bunnapradist S, Pham T, Danovitch G. (2017). Acute kidney allograft rejection precipitated by lenalidomide treatment for multiple myeloma. Am J Kidney Dis. (65 year old woman developed multiple myeloma 5 years after a successful renal transplant for polycystic kidney disease and developed acute cellular rejection during a second cycle of lenalidomide and dexamethasone that improved with immunosuppression and withdrawal of lenalidomide, later tolerating bortezomib therapy of myeloma).
Tsukune Y, Sasaki M, Odajima T, Sunami K, Takei T, Moriuchi Y, Iino M, et al. (2017). Incidence and risk factors of hepatitis B virus reactivation in patients with multiple myeloma in an era with novel agents: a nationwide retrospective study in Japan. Blood Cancer J. (Japanese nationwide analysis of 5078 patients with multiple myeloma identified 760 with resolved hepatitis B [anti-HBc without HBsAg in serum] of whom 7.6% developed reactivation [7.9% at 2 and 14.1% at 5 years], multivariate analysis demonstrating higher rates in those undergoing autologous hematopoietic stem cell transplant [21%:odds ratio=11.6] and lower rates in those receiving lenalidomide [5.2%:odds ratio=0.5], but not thalidomide, bortezomib or dexamethasone).
Hammami MB, Talkin R, Al-Taee AM, Schoen MW, Goyal SD, Lai JP. (2018). Autologous graft-versus-host disease of the gastrointestinal tract in patients with multiple myeloma and hematopoietic stem cell transplantation. Gastroenterology Res. (Two patients with multiple myeloma who underwent autologous hematopoietic cell transplantation developed autologous graft-vs-host disease with moderately severe gastrointestinal involvement after receiving several cycles of lenalidomide and dexamethasone).
Azmy V, Neparidze N. (2018). Hyperbilirubinemia following lenalidomide administration. Clin Case Rep. (72 year old man with multiple myeloma developed hyperbilirubinemia after a first cycle of lenalidomide [bilirubin 3.9 with normal direct bilirubin, ALT and Alk P] suspected to be due to Gilbert syndrome).
Kikuchi T, Kusumoto S, Tanaka Y, Oshima Y, Fujinami H, Suzuki T, Totani H, et al. (2020). Hepatitis B virus reactivation in a myeloma patient with resolved infection who received daratumumab-containing salvage chemotherapy. J Clin Exp Hematop. (72 year old women with multiple myeloma who was negative for HBsAg but positive for anti-HBc without anti-HBs was monitored and had no evidence for reactivation during multiple courses of bortezomib, melphalan, dexamethasone, lenalidomide and pomalidomide over a 3 year period, but then developed HBV DNA [2.2 to 2.6 log_10_ per mL] and HBsAg after 3^rd^ course of daratumumab with bortezomib and dexamethasone with rapid response upon addition of entecavir).
Vaxman I, Eaton J, Lee HE, Gertz MA. (2020). Acute liver rejection in a multiple myeloma patient treated with lenalidomide. Case Rep Transplant. (65 year old woman with primary biliary cirrhosis and liver transplant developed multiple myeloma 9 years later and acute cellular rejection 2 weeks after starting therapy with lenalidomide and dexamethasone [bilirubin 3.3 mg/dL, ALT 306 U/L, Alk P 253 U/L], responding to restarting mycophenolate and starting high dose methylprednisolone and tacrolimus).

## OTHER REFERENCE LINKS

1 Recent References on Lenalidomide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lenalidomide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Lenalidomide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lenalidomide)